# Topoisomerase Inhibitors

## OVERVIEW

Topoisomerase I and II are normal host enzymes that are found in the nucleus of mammalian cells and are required for normal DNA replication and cellular division. The enzymes create and then repair single stranded nicks in cellular DNA. The nicks allow for the untangling and relaxation of supercoiled double stranded DNA, so that replication can proceed. Once the DNA torsional strain has been relieved, the topoisomerase reseals the relaxed double helix. Topoisomerase activity is particularly increased in rapidly dividing and in cancer cells. It represents an appropriate, but nonselective target for anticancer therapy.

Topoisomerase inhibitors in current use in the United States include irinotecan and topotecan, inhibitors of topoisomerase I, and etoposide and teniposide, inhibitors of topoisomerase II. All four agents are semisynthetic analogues of natural toxins that were initially identified in plants. All four are given parenterally, typically in combination with other antineoplastic agents in cycles of every 3 to 4 weeks. The major dose limiting toxicities of topoisomerase inhibitors are largely hematologic (neutropenia, anemia, thrombocytopenia) and gastrointestinal (diarrhea, nausea). While serum enzyme elevations are not uncommon with chemotherapeutic regimens that include topoisomerase inhibitors, clinically apparent liver injury is uncommon.

Irinotecan and topotecan are derived from camptothecins, cytotoxic compounds which were initially isolated from the bark of the Chinese tree, Camptotheca acuminata. These agents bind to the DNA-topoisomerase I complex and prevent resealing of the DNA. Accumulation of DNA breaks results in inhibition of DNA replication and cell death. Once the mechanism of toxicity of camptothecins was elucidated, more soluble and less toxic analogues were produced. Irinotecan and topotecan are two camptothecin derivatives currently in use in the United States and are used as adjunctive therapies for advanced colorectal, ovarian and small cell lung cancer.

Etoposide and teniposide are semisynthetic derivatives of extracts of the American mandrake plant or Mayapple (Podophyllum peltatum) and bind to topoisomerase II and DNA, preventing the resealing of DNA breaks and thus causing inhibition of DNA replication and cell death. These agents are in current use as adjunctive therapies for advanced testicular and small cell lung cancer (etoposide, originally called VP-16), and for acute leukemia in children and malignant brain tumors (teniposide, VP-26).

A more complete discussion of the current use and hepatotoxicity and references are provided with each agent individually.

Drug Class: Antineoplastic Agents

Drugs in the Subclass Topoisomerase Inhibitors:

- Etoposide
- Irinotecan
- Teniposide
- Topotecan

## ANNOTATED BIBLIOGRAPHY

References updated: 12 September 2020

Wellstein A, Giaccone G, Atkins MB, Sausville EA. Camptothecin analogues. Cytotoxic agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1189-90. (Textbook of pharmacology and therapeutics; mentions that irinotecan and topotecan are the only camptothecin analogues approved for clinical use and have activity in colorectal, ovarian and small cell lung cancer, and both can cause elevations in serum aminotransferase levels).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Epipodophyllotoxins. Cytotoxic agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1192-3. (Textbook of pharmacology and therapeutics; mentions that etoposide and teniposide [VP-16 and VP-26] are semisynthetic derivatives of podophyllotoxin, an extract from the mandrake plant or mayapple [Podophyllum peltatum], which bind to topoisomerase 2 and DNA and preempt resealing of DNA breaks that occur during DNA replication).